# Abatacept

## OVERVIEW

### Introduction

Abatacept is a recombinant fusion protein of the cell surface marker CTLA-4 and a fragment of immunoglobulin G that acts by interfering with T cell activation and is used to treat rheumatoid and psoriatic arthritis and juvenile idiopathic arthritis. Abatacept has been linked to a low rate of serum enzyme elevations during therapy, and to rare cases of idiosyncratic, clinically apparent liver injury with jaundice. Because abatacept is a potent inhibitor of lymphocyte function, it can cause reactivation of hepatitis B in susceptible patients.

### Background

Abatacept (a bat' a sept) is a recombinant fusion protein that combines the extracellular domain of the cytotoxic T lymphocyte associated antigen-4 (CTLA-4) with the heavy chain fragment of immunoglobulin G. Abatacept blocks the actions of CTLA-4, which is important in the co-stimulatory pathway of activation of T cells. Blocking CTLA-4 inhibits maturation and activation of T cells, T cell proliferation and production of proinflammatory cytokines, such as tumor necrosis factor (TNF), interferon gamma and interleukin 2 and 6. Abatacept has been evaluated in several autoimmune inflammatory conditions, including rheumatoid and psoriatic arthritis, lupus erythematosus and inflammatory bowel disease. Abatacept was approved for use in the United States in 2005, and current formal indications include moderately severe rheumatoid and psoriatic arthritis in adults and juvenile idiopathic arthritis in children 2 years of age or above. Abatacept is available under the brand name Orencia as a lyophilized power for intravenous administration in single use vials of 250 mg and as a solution for subcutaneous administration in single use syringes of 50, 75, and 125 mg or in autoinjectors of 125 mg/mL. In adults, abatacept may be given subcutaneously or intravenously (at weeks 0, 2, 4 and then every 4 weeks) in doses based upon body weight ranging from 500 to 1000 mg. The dose in children is based upon body weight and given either intravenously or subcutaneously at weeks 0, 2, 4 and then every 4 weeks. Common side effects include infusion reactions of chills, fever and hypertension and nonspecific symptoms of headache, dizziness, nausea, back and body pain, nasopharyngitis, and rash. Acute hypersensitivity reactions occur in <1% of patients and anaphylaxis in <0.1%. Less common, but potentially severe side effects include an increased risk of infections and reactivation of tuberculosis and hepatitis B.

### Hepatotoxicity

In prelicensure controlled trials, serum ALT elevations occurred in 2% to 3% of abatacept and a similar proportion of placebo treated subjects. The elevations were usually mild-to-moderate in severity, asymptomatic and self-limited in course. ALT elevations above 5 times the upper limit of normal (ULN) occurred <1% of abatacept recipients, and only rare patients had to stop therapy because of serum enzyme elevations. Clinically apparent liver injury is not listed as a potential side effect in the product label for abatacept, but there has been at least one case report of acute liver injury with symptoms or jaundice attributed to abatacept: a case of severe acute hepatitis accompanied by ANA positivity and a response to corticosteroid therapy (Case 1). Thus, abatacept may precipitate an acute autoimmune hepatitis but this is quite rare.

Abatacept is a potent immunosuppressive agent and reactivation of hepatitis B in patients with ongoing or previous hepatitis B can occur. Reactivation is most frequent in patients with HBsAg in serum whether or not they have accompanying chronic hepatitis. Yet reactivation can also occur, although more rarely, in persons with resolved hepatitis B, who have anti-HBc but no HBsAg detectable in serum. With reactivation, serum levels of HBV DNA rise, followed by increases in serum ALT and AST and then symptoms and jaundice. The injury is hepatocellular and resembles acute hepatitis B. The onset of liver injury is usually after 3 to 12 monthly injections of the immunomodulatory agent in patients with HBsAg in serum. In patients with resolved hepatitis B, however, the time to reactivation is often much longer and may only arise after 1 to 10 or more years of immunosuppressive therapy. In studies from Taiwan, reactivation of hepatitis B attributed to abatacept were reported in up to 9% of treated subjects after 1 to more than 10 years of therapy, at a yearly rate of approximately 1 per 100 patients who had anti-HBc without HBsAg in serum. Reactivation was accompanied by ALT elevations in half and decompensation and death in a proportion. For these reasons, screening for hepatitis B markers is recommended before starting abatacept and regular monitoring for rises in HBV DNA levels during therapy is recommended for those with anti-HBc with or without HBsAg in serum. With evidence of reactivation (de novo appearance or rise in HBV DNA levels), antiviral therapy should be initiated using an agent with potent activity against HBV such as entecavir or tenofovir. The other option is prophylaxis with one of these antiviral agents.

Likelihood score: C (probable rare cause of clinically apparent liver injury including reactivation of hepatitis B in susceptible patients).

### Mechanism of Injury

Abatacept is a recombinant human protein and as such is unlikely to be intrinsically hepatotoxic. Because it has immunomodulatory actions, it can cause reactivation of hepatitis B or induce an autoimmune liver reaction.

### Outcome and Management

Abatacept has been linked to minor serum enzyme elevations and to rare instances of acute liver injury with jaundice. Discontinuation for serum enzyme elevations is rarely necessary, but should be done if the elevations are accompanied by symptoms or jaundice or for persistent ALT elevations of more than 5 times ULN. There is no information on cross sensitivity to liver injury between abatacept and other immunomodulatory cytokines. Reactivation of hepatitis B can occur with abatacept therapy and patients with preexisting HBsAg or anti-HBc without HBsAg should be given antiviral prophylaxis or monitored regularly for early evidence of reactivation, with prompt initiation of antiviral therapy using an agent with potent activity against HBV, such as entecavir or tenofovir.

Drug Class: Antirheumatic Agents

## CASE REPORT

### Case 1. Acute liver injury attributed to abatacept therapy.(1)

A 61 year old Japanese woman with Sjögren syndrome and rheumatoid arthritis developed epigastric pain and nausea after four infusions of abatacept. She had been treated previously with methotrexate, infliximab, adalimumab, tacrolimus and tocilizumab without a lasting response. She had no history of liver disease, drug allergies, risk factors for viral hepatitis or alcohol abuse. Physical examination showed jaundice and epigastric tenderness. Laboratory tests show a total bilirubin of 15.2 mg/dL (12.1 mg/dL direct) with an ALT of 2217 U/L, AST 4310 U/L, alkaline phosphatase 1388 U/L and prothrombin time index 50%. Tests for hepatitis A, B (including HBV DNA) and C were negative, as were IgM antibodies to cytomegalovirus and Epstein Barr virus. The ANA was positive (1:1280), IgG was elevated (2,030 mg/dL) and rheumatoid factor was present (56.8 IU/mL), but SMA and AMA were negative. Over the next few weeks, she worsened with serum bilirubin rising to 24 mg/dL, prothrombin activity falling to 40% and appearance of hepatic encephalopathy and ascites. She was treated with high doses of methylprednisolone and plasma exchange. She was evaluated for emergency liver transplantation, but then began to improve spontaneously. Over the next several months, liver tests improved and were normal 6 months later.

#### Key Points

Medication: | Abatacept (500 mg, four intravenous infusions)
Pattern: | Mixed (R=4.6)
Severity: | 4+ (jaundice, hospitalization, abnormal INR, hepatic coma)
Latency: | ~6 weeks
Recovery: | ~8 weeks
Other medications: | None concurrently

#### Comment

This case is an example of an acute hepatitis with a "mixed" pattern of serum enzyme elevations and severe course arising after 4 to 6 weeks of abatacept therapy of rheumatoid arthritis. Other common causes of acute liver injury were excluded. Tests for hepatitis B documented that the hepatitis was not due to reactivation. Autoimmune features were present, including high titers of ANA and elevations in IgG levels, but these might also have been present because of the underlying disease. Nonetheless, the course and outcome are most compatible with an autoimmune hepatitis induced by the immunomodulatory agent. This reaction must be quite rare.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Abatacept – Orencia®

DRUG CLASS

Antirheumatic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=abatacept)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Abatacept | 332348-12-6 | Recombinant Protein | Not Available

## CITED REFERENCES

1 Iwanaga N, Origuchi T, Terada K, Ueki Y, Kamo Y, Kinoshita N, Yonemitsu N, et al. (2014). Rheumatoid arthritis complicated with severe liver injury during treatment with abatacept. Mod Rheumatol.

## ANNOTATED BIBLIOGRAPHY

References updated: 06 October 2021

Abbreviations: Anti-TNF, anti-tumor necrosis factor; DMARDs, disease modifying antirheumatic drugs; HBV, hepatitis B virus.

Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents; mentions that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists").
Krensky AM, Azzi JR, Hafler DA. Immunosuppressants and tolerogens. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 637-53. (Textbook of pharmacology and therapeutics).
Kremer JM, Westhovens R, Leon M, Di Giorgio E, Alten R, Steinfeld S, Russell A, et al. (2003). Treatment of rheumatoid arthritis by selective inhibition of T-cell activation with fusion protein CTLA4Ig. N Engl J Med. (Among 339 patients with rheumatoid arthritis not responding adequately to methotrexate who were treated with 1 of 2 doses of abatacept or placebo for six months, response rates were 60% with higher doses of abatacept, 42% with lower doses, and 35% with placebo, while rates of adverse events were similar and no serious adverse event was attributed to drug; no mention of ALT elevations or hepatotoxicity).
Genovese MC, Becker JC, Schiff M, Luggen M, Sherrer Y, Kremer J, Birbara C, et al. (2005). Abatacept for rheumatoid arthritis refractory to tumor necrosis factor alpha inhibition. N Engl J Med. (Among 389 patients with rheumatoid arthritis not responding to anti-TNF agents who were treated with abatacept or placebo for 6 months, clinical responses occurred with 50% of abatacept vs 20% of placebo recipients and overall rates of side effects were similar, although abatacept recipients were more likely to have infections [38% vs 32%] and acute infusion reactions [5% vs 3%]).
(2006). Abatacept (Orencia) for rheumatoid arthritis. Med Lett Drugs Ther. (Concise review of the mechanism of action, efficacy, safety and costs of abatacept for rheumatoid arthritis; discussion of adverse events includes mention of increased rates of infections, especially when combined with anti-TNF agents).
Schiff M, Keiserman M, Codding C, Songcharoen S, Berman A, Nayiager S, Saldate C, et al. (2008). Efficacy and safety of abatacept or infliximab vs placebo in ATTEST: a phase III, multi-centre, randomised, double-blind, placebo-controlled study in patients with rheumatoid arthritis and an inadequate response to methotrexate. Ann Rheum Dis. (Among 416 patients with rheumatoid arthritis not responding to methotrexate who were treated with abatacept, infliximab or placebo for 6 months, clinical responses were similar for abatacept and infliximab and side effect rates were similar).
Khraishi M, Russell A, Olszynski WP. (2010). Safety profile of abatacept in rheumatoid arthritis: a review. Clin Ther. (Systematic review of the literature on safety of abatacept including analysis of 7 placebo controlled trials and 5 with long term follow up; no mention of ALT elevations of hepatotoxicity).
Ruperto N, Lovell DJ, Quartier P, Paz E, Rubio-Pérez N, Silva CA, Abud-Mendoza C, et al., Paediatric Rheumatology International Trials Organization and the Pediatric Rheumatology Collaborative Study Group. (2010). Long-term safety and efficacy of abatacept in children with juvenile idiopathic arthritis. Arthritis Rheum. (Among 153 children with juvenile idiopathic arthritis treated with abatacept in a long term extension study, none developed a severe hepatic adverse reaction; no mention of ALT elevations).
Genovese MC, Covarrubias A, Leon G, Mysler E, Keiserman M, Valente R, Nash P, et al. (2011). Subcutaneous abatacept versus intravenous abatacept: a phase IIIb noninferiority study in patients with an inadequate response to methotrexate. Arthritis Rheum. (Among 1457 patients with rheumatoid arthritis treated with either intravenous or subcutaneous abatacept for 6 months, both beneficial responses and adverse events were similar in the two groups; no mention of ALT elevations or hepatotoxicity ).
Mease P, Genovese MC, Gladstein G, Kivitz AJ, Ritchlin C, Tak PP, Wollenhaupt J, et al. (2011). Abatacept in the treatment of patients with psoriatic arthritis: results of a six-month, multicenter, randomized, double-blind, placebo-controlled, phase II trial. Arthritis Rheum. (Among 170 patients with psoriatic arthritis treated with 1 of 3 doses of abatacept or placebo for 6 months, response rates were 33%, 48% and 42% in the abatacept and 19% in the placebo group, and side effects were slightly higher with high dose abatacept; no mention of ALT elevations or hepatotoxicity).
(2012). Drugs for rheumatoid arthritis. Treat Guidel Med Lett. (Concise review of therapy of rheumatoid arthritis mentions that abatacept can cause acute infusion reactions and probably increases the risk for serious infections, but not tuberculosis).
Grasland A, Sterpu R, Boussoukaya S, Mahe I. (2012). Autoimmune hepatitis induced by adalimumab with successful switch to abatacept. Eur J Clin Pharmacol. (35 year old woman with seronegative arthritis developed rise in ALT [from 18 to 266 U/L, ANA 1:80, SMA 1:320] two months after starting adalimumab, which fell to normal on stopping adalimumab and substituting prednisone; in follow up the liver injury did not recur on starting abatacept).
Sandborn WJ, Colombel JF, Sands BE, Rutgeerts P, Targan SR, Panaccione R, Bressler B, et al. (2012). Abatacept for Crohn's disease and ulcerative colitis. Gastroenterology. (Pooled results from 4 controlled trials of abatacept in inflammatory bowel disease showing little evidence of efficacy and an increase in adverse events compared to placebo; no mention of ALT elevations or hepatotoxicity).
Germanidis G, Hytiroglou P, Zakalka M, Settas L. (2012). Reactivation of occult hepatitis B virus infection, following treatment of refractory rheumatoid arthritis with abatacept. J Hepatol. (70 year old woman with long term refractory rheumatoid arthritis and anti-HBc without HBsAg in serum developed detectable HBV DNA [12,000 IU/mL] and low levels of HBsAg serum, with ALT levels rising to 10 times ULN, and with resolution of hepatitis and clearance of HBV DNA within 4 months of starting tenofovir therapy).
Kim PS, Ho GY, Prete PE, Furst DE. (2012). Safety and efficacy of abatacept in eight rheumatoid arthritis patients with chronic hepatitis B. Arthritis Care Res (Hoboken). (Retrospective study of 8 patients with refractory rheumatoid arthritis who were treated with abatacept for 3-33 months who were known to be HBsAg positive, 4 received anti-HBV prophylaxis and all 4 responded to treatment and none had reactivation, whereas the 4 who did not receive prophylaxis had minimal response to treatment and all four had reactivation at 3-27 months, although none had hepatitis as antiviral therapy was evidently started promptly).
Weinblatt ME, Moreland LW, Westhovens R, Cohen RB, Kelly SM, Khan N, Pappu R, et al. (2013). Safety of abatacept administered intravenously in treatment of rheumatoid arthritis: integrated analyses of up to 8 years of treatment from the abatacept clinical trial program. J Rheumatol. (Analysis of pooled results from 8 clinical trials of intravenous abatacept including data on 3173 patients for up to 8 years of treatment found no increase in rates of adverse events with long term therapy; no mention of ALT elevations or hepatotoxicity).
Fanouriakis A, Vassilopoulos D, Repa A, Boumpas DT, Sidiropoulos P. (2014). Hepatitis B reactivation following treatment with abatacept in a patient with past hepatitis B virus infection. Rheumatology (Oxford). (68 year old woman with rheumatoid arthritis and anti-HBc without HBsAg in serum developed HBsAg 10 months after starting abatacept with high levels of HBV DNA [108 IU/mL] and brief period of ALT elevation after starting tenofovir, but ultimate clearance of HBV DNA and normal liver tests).
Westhovens R, Kremer JM, Emery P, Russell AS, Alten R, Barré E, Dougados M. (2014). Long-term safety and efficacy of abatacept in patients with rheumatoid arthritis and an inadequate response to methotrexate: a 7-year extended study. Clin Exp Rheumatol. (Analysis of long term open-label extension study of abatacept in 219 patients with psoriasis, of whom 114 were still receiving drug after 7 years, found sustained clinical benefits and no increase in rates of adverse events; no mention of ALT elevations or hepatotoxicity and no episodes of tuberculosis).
Takeuchi T, Matsubara T, Urata Y, Suematsu E, Ohta S, Honjo S, Abe T, et al., Japan Abatacept Study Group. (2014). Phase III, multicenter, open-label, long-term study of the safety of abatacept in Japanese patients with rheumatoid arthritis and an inadequate response to conventional or biologic disease-modifying antirheumatic drugs. Mod Rheumatol. (Among 217 Japanese patients with rheumatoid arthritis treated intravenously with abatacept for an average of 3 years, response rates ranged from 61-81% and were sustained; ALT elevations occurred in 11.5%, but none were considered serious; no mention of reactivation of hepatitis B and no patient developed tuberculosis).
Furie R, Nicholls K, Cheng TT, Houssiau F, Burgos-Vargas R, Chen SL, Hillson JL, et al. (2014). Efficacy and safety of abatacept in lupus nephritis: a twelve-month, randomized, double-blind study. Arthritis Rheumatol. (Among 298 patients with lupus nephritis treated with 2 doses of abatacept or placebo for 12 months, response rates were similar in all three groups, and adverse events were similar except for higher rates of infection with abatacept; no mention of ALT elevations or hepatotoxicity).
Iwanaga N, Origuchi T, Terada K, Ueki Y, Kamo Y, Kinoshita N, Yonemitsu N, et al. (2014). Rheumatoid arthritis complicated with severe liver injury during treatment with abatacept. Mod Rheumatol. (61 year old woman with Sjögren syndrome and rheumatoid arthritis developed nausea after 4 infusions of abatacept [bilirubin 15.2 mg/dL, ALT 2217 U/L, Alk P 1388 U/L, prothrombin activity 50%, ANA 1:1280], progressing to hepatic failure, treated with corticosteroids and plasma exchange, and ultimately resolving within 2 months of onset: Case 1).
Alten R, Kaine J, Keystone E, Nash P, Delaet I, Genovese MC. (2014). Long-term safety of subcutaneous abatacept in rheumatoid arthritis: integrated analysis of clinical trial data representing more than four years of treatment. Arthritis Rheumatol. (Among 1879 patients with rheumatoid arthritis treated with subcutaneous abatacept for an average of 2.2 years in 5 clinical trials, serious adverse events included serious infections [1.8% per year], malignancy [1.3%], autoimmune conditions [1.4%], injection site reactions [1.7%], and 4 cases of tuberculosis, one fatal; ALT elevations occurred in 2.4% of patients, but there were no liver related serious adverse events).
Lovell DJ, Ruperto N, Mouy R, Paz E, Rubio-Pérez N, Silva CA, Abud-Mendoza C, et al., Pediatric Rheumatology Collaborative Study Group and the Paediatric Rheumatology International Trials Organisation. (2015). Long-term safety, efficacy, and quality of life in patients with juvenile idiopathic arthritis treated with intravenous abatacept for up to seven years. Arthritis Rheumatol. (Among 153 children [ages 6-17 years] with juvenile idiopathic arthritis treated with abatacept in 43 centers for up 7 years, 30 [20%] had a serious adverse event [mostly infections and autoimmune events], but none were liver related; ALT elevations not mentioned).
Padovan M, Filippini M, Tincani A, Lanciano E, Bruschi E, Epis O, Garau P, et al. (2016). Safety of abatacept in rheumatoid arthritis with serological evidence of past or present hepatitis B virus infection. Arthritis Care Res (Hoboken). (Among 51 patients with rheumatoid arthritis and HBsAg and 21 with anti-HBc without HBsAg who were treated with abatacept for up to 4 years, none developed HBV reactivation or de novo HBsAg even though most [76%] did not receive antiviral prophylaxis).
Harigai M, Ishiguro N, Inokuma S, Mimori T, Ryu J, Takei S, Takeuchi T, et al. (2016). Postmarketing surveillance of the safety and effectiveness of abatacept in Japanese patients with rheumatoid arthritis. Mod Rheumatol. (Among 3882 Japanese patients wtih rheumatoid arthritis treated with abatacept for an average of 6 months, liver test abnormalities were reported in 0.75% and were considered serious in 0.05%, but no death was due to liver disease and there was no mention of hepatitis or reactivation of hepatitis B).
Talotta R, Atzeni F, Sarzi Puttini P. (2016). Reactivation of occult hepatitis B virus infection under treatment with abatacept: a case report. BMC Pharmacol Toxicol. (66 year old man with rheumatoid arthritis and anti-HBc without HBsAg or anti-HBs in serum developed detectable serum HBV DNA [326 IU/mL] 11 months after starting abatacept [750 mg each month] with minimal ALT elevations and no symptoms and was started on lamivudine when repeat HBV DNA was positive [1416 IU/mL], with subsequent lack of detectable HBV DNA and normal ALT levels).
Papalopoulos I, Fanouriakis A, Kougkas N, Flouri I, Sourvinos G, Bertsias G, Repa A, et al. (2018). Liver safety of non-tumour necrosis factor inhibitors in rheumatic patients with past hepatitis B virus infection: an observational, controlled, long-term study. Clin Exp Rheumatol. (Among 156 patients with inflammatory arthritidies and anti-HBc without HBsAg in serum who were treated with biologic DMARDs for an mean of 24 months, none of 85 receiving anti-TNF therapy developed reactivation of hepatitis B compared to 2 of 71 receiving other biologics, including rituximab 1 of 32 on rituximab, 1 of 39 on abatacept and none of 30 on tocilizumab).
Watanabe T, Fukae J, Fukaya S, Sawamukai N, Isobe M, Matsuhashi M, Shimizu M, et al. (2019). Incidence and risk factors for reactivation from resolved hepatitis B virus in rheumatoid arthritis patients treated with biological disease-modifying antirheumatic drugs. Int J Rheum Dis. (Among 152 Japanese patients with rheumatoid arthritis and anti-HBc without HBsAg in serum who were treated with DMARDs for an average of 13 months, only 7 developed evidence of reactivation but none required antiviral therapy, HBV DNA remaining low or becoming undetectable and ALT remaining normal in all; reactivation occurring in 3 of 7 [43%] with vs 90% without anti-HBs at baseline and in 3 of 29 [10%] on abatacept, 2 of 17 [12%] infliximab, 1 of [4%] golimumab, 1 of 25 tocilizumab, but none on etanercept, adalimumab, or on methotrexate and steroids alone).
Cambier ML, Canestri A, Lependeven C, Peltier J, Mesnard L, Dahan K. (2019). Hepatitis B virus reactivation during belatacept treatment after kidney transplantation. Transpl Infect Dis. (47 year old man with HIV infection, end-stage renal disease and anti-HBc without HBsAg in serum, underwent kidney transplantation with long term belatacept, prednisone and mycophenolate as well as anti-HIV therapy with darunavir/R, etravirine and raltegravir and developed reactivation of HBV with an acute hepatitis, which responded to entecavir therapy with subsequent loss of HBV DNA).
Chen MH, Chen MH, Chou CT, Hou MC, Tsai CY, Huang YH. (2020). Low but long-lasting risk of reversal of seroconversion in patients with rheumatoid arthritis receiving immunosuppressive therapy. Clin Gastroenterol Hepatol. (Among 1434 adults with rheumatoid arthritis treated between 2007 and 2018 at a single Taiwanese referral center, 925 initially had anti-HBc without HBsAg in serum among whom in follow up 17 developed HBsAg [2%], all with detectable HBV DNA in serum [>100,000 IU/mL in most], 8 with ALT elevations above 3 times ULN, 3 with hepatic decompensation and one died despite entecavir therapy once reactivation was detected; reactivation occurred in 16 of 473 [3.3%] who received a biologic agent for 10 to 105 [median=66] months including rituximab [n=9], adalimumab [n=2], abatacept [n=4] and etanercept [n=1] vs only 1 of 452 [0.2%] who received conventional DMARDs only).
Teraoka Y, Imamura M, Uchida T, Ohya K, Morio K, Fujino H, Ono A, et al. (2021). Abatacept treatment for patients with severe acute hepatitis caused by hepatitis B virus infection-Pilot study. J Viral Hepat. (Among 5 patients with severe acute hepatitis B treated with abatacept as well as with either entecavir or tenofovir, all had improvements in serum aminotransferase levels and hepatitis B markers and reportedly suffered on adverse reactions from therapy although the outcome in one case was not provided).
Chen MH, Lee IC, Chen MH, Hou MC, Tsai CY, Huang YH. Abatacept is second to rituximab at risk of HBsAg reverse seroconversion in patients with rheumatic disease. Ann Rheum Dis. 2021 Jun 29:annrheumdis-2021-220774. ePub ahead of print. (Among 1937 patients with rheumatoid arthritis started on DMARDs therapy between 2003 and 2019, 489 had anti-HBc without HBsAg in serum, of whom 27 [5.5%] developed HBsAg and reactivation of hepatitis B during biologic DMARDs therapy, typically after 10 months to 15 years, the rate being highest for rituximab at 18 of 84 patients or 17 per 1000 person years [ptpy] and abatacept at 6 of 69 patients or 9 ptpy and lower for anti-TNF agents [etanercept 1, adalimumab 2] at 3 of 255 or 1 ptpy).

## OTHER REFERENCE LINKS

1 Recent References on Abatacept: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Abatacept+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Abatacept: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Abatacept)